# Meperidine

## OVERVIEW

### Introduction

Meperidine is a synthetic opioid which has been used widely for therapy of moderate-to-severe pain. Meperidine has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Meperidine (me per’ i deen: known as pethidine in other countries) is a fully synthetic opioid that is similar, but not fully equal in potency to morphine and has different pharmacokinetics and spectrum of action. Meperidine acts by engagement in cell surface opiate receptors (predominant µ type receptors) that are found in the central nervous system, but also heart, lung, vascular and intestinal cells. Meperidine also has anticholinergic activity. Current indications are for moderate-to-severe pain, pre- and postoperative analgesia, and as an adjunct to anesthesia. Meperidine was approved for use in the United States in 1942 and for many years was the opioid of choice for severe pain. In recent years, concerns about its safety and unique side effects have led to a decrease in its use. Meperidine is available generically and under the brand name Demerol as tablets of 50 and 100 mg, as an oral solution of 50 mg/5 mL, and as a solution for injection in concentrations of 25, 50, 75 and 100 mg/mL. Typical oral doses of meperidine in adults are 50 to 150 mg every 3 to 4 hours, as needed. Side effects include sedation, respiratory depression, confusion, euphoria, agitation, constipation, abdominal bloating, nausea, vomiting and constipation which are typical of the opioids. Meperidine is also, somewhat uniquely, associated with seizures, delirium and neuropsychological effects that are not well explained purely by opiate pathways. Meperidine is a controlled substance and classified as a Schedule II drug, indicating that it has medical usefulness, but also a high potential for physical and psychological dependency and abuse.

### Hepatotoxicity

Therapy with meperidine has not been linked to serum enzyme elevations. There have been no convincing cases of idiosyncratic acute, clinically apparent liver injury attributed to meperidine.

References on the safety and potential hepatotoxicity of meperidine are given in the Overview section of the Opioids.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Meperidine – Generic, Demerol®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Meperidine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Meperidine | 50-13-5 | C15-H21-N-O2.Cl-H | Meperidine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Meperidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Meperidine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Meperidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Meperidine)